# Pindolol

## OVERVIEW

### Introduction

Pindolol is a nonselective beta adrenergic receptor blocker that is widely used for the therapy of hypertension and angina pectoris. Pindolol has yet to be convincingly associated with clinically apparent liver injury.

### Background

Pindolol (pin' doe lol) is a nonselective beta blocker, acting on both beta-1 and beta-2 adrenergic receptors. Beta-1 adrenergic blockade reduces the heart rate and myocardial contractility by slowing the AV conduction and suppressing automaticity. Beta-2 blockade affects peripheral vascular resistance and can cause bronchospasm and hypoglycemia. Pindolol is also a partial adrenergic receptor agonist and has mild sympathomimetic activity. Pindolol was approved for use in the United States in 1982 and remains in wide use, current indications being treatment of hypertension either alone or in combination with other antihypertensive medications. Pindolol is available in tablets of 5 and 10 mg in generic forms and under the trade name Visken. The typical initial oral dose of pindolol in adults is 5 mg twice daily, with subsequent dose modification based upon clinical response and tolerance, the average total daily maintenance dose being 10 to 60 mg. Common side effects of pindolol include bradycardia, hypotension, fatigue, dizziness, depression, memory loss, impotence, cold limbs and, less commonly, severe hypotension, heart failure and bronchospasm. Sudden withdrawal can trigger rebound hypertension. Beta-blockers are contraindicated in patients with asthma, bradycardia and heart failure and should be used cautiously in the elderly and in patients with diabetes.

### Hepatotoxicity

Mild-to-moderate elevations in serum aminotransferase levels occur in less than 2% of patients on pindolol and are usually transient and asymptomatic, resolving even with continuation of therapy. Despite its wide spread use, pindolol has not been convincingly linked to instances of clinically apparent liver injury. Other beta-blockers have been implicated in rare instances of clinically apparent liver injury with a latency to onset ranging from 4 to 24 weeks, a hepatocellular pattern of serum enzyme elevations, and a mild, self-limiting course without evidence of hypersensitivity or autoimmune reactions.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Pindolol undergoes metabolism by the liver and is excreted in the urine both unchanged and as inactive metabolites. The reason why pindolol rarely causes liver injury is unknown; other beta-blockers with similar chemical structures have been linked to cases of clinically apparent, idiosyncratic liver injury.

References to the safety and potential hepatotoxicity of pindolol are provided in the overview on Beta-Adrenergic Receptor Antagonists, last updated in June 2019.

Drug Class: Beta-Adrenergic Receptor Antagonists

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pindolol – Generic, Visken®

DRUG CLASS

Beta-Adrenergic Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=pindolol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pindolol | 13523-86-9 | C14-H20-N2-O2 | Pindolol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Pindolol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Pindolol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Pindolol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pindolol)